# Inebilizumab

Short Chapter

[Preliminary review chapter based on the FDA Product Labeling and Integrated Review only.]

## OVERVIEW

### Introduction

Inebilizumab is a monoclonal antibody to CD19 that is used to treat adults with neuromyelitis optica spectrum disorder accompanied by an autoantibody to aquaporin-4. Inebilizumab therapy is associated with an increased risk of infections and possibly reactivation of hepatitis B and tuberculosis, but it has not been associated with serum aminotransferase elevations during therapy or to instances of clinically apparent liver injury.

### Background

Inebilizumab (in eb” i liz’ ue mab) is a humanized, cytolytic monoclonal antibody to CD19 that is used to treat adults with neuromyelitis optica spectrum disorder (NMOSD), a severe neurologic disease marked by bilateral optic neuritis and transverse myelitis that is accompanied by a distinctive autoantibody to aquaporin-4 (antiAQP4). In many ways, NMOSD resembles multiple sclerosis (MS) and is similarly marked by spontaneous relapses and remissions. Yet NMOSD differs from MS by the absence of typical brain findings on magnetic resonance imaging and by the presence of antiAQP4, a possibly pathogenic antibody. Inebilizumab dramatically lowers peripheral B cells, and chronic therapy is effective in lowering immunoglobulin levels and reducing relapses of NMSOD. Inebilizumab was approved for treatment of adults with neuromyelitis optica spectrum disorder positive for anti-AQP4 in the United States in 2020. Inebilizumab is available in solution in single use vials of 100 mg/10mL under the brand name Uplizna. The recommended dose regimen is 300 mg by intravenous infusion at time 0 and 2 weeks later, followed by every 6 months. Patients should be screened for hepatitis B and tuberculous before starting therapy and should have serum immunoglobulin levels measured and be given any needed live viral vaccines beforehand. Premedication with acetaminophen, antihistamines, or corticosteroids is recommended. In prelicensure trials, common adverse events included infusion reactions, reduction in immunoglobulin levels, arthralgias, and urinary tract infections. Serious adverse events associated with inebilizumab therapy include severe infections, hypersensitivity reactions, and embryo-fetal toxicity. Because it lowers peripheral B cells, inebilizumab may cause reactivation of tuberculosis, hepatitis B, and herpes virus infections, and possibly lead to progressive multifocal leukoencephalitis.

### Hepatotoxicity

In registration controlled trials, serum ALT elevations occurred in 21% of inebilizumab vs 23% of placebo recipients and were above 3 times the upper limit of normal (ULN) in 5 of 161 (3.1%) on inebilizumab vs only 1 of 51 (2%) on placebo. One patient receiving inebilizumab developed acute cholangitis with ALT and AST elevations above 5 times ULN but without jaundice and responding rapidly to antibiotics and biliary drainage. Since the approval of inebilizumab in 2020, there have been no case reports of clinically apparent liver injury attributed to its use. Monoclonal antibodies to CD19 have been used for other indications and similarly have been free of liver injury. These B cell directed monoclonal antibodies, however, are considered possible causes of reactivation of hepatitis B and prescreening for hepatitis B status is often recommended.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The causes of the mild liver test abnormalities during inebilizumab therapy are not clearly known but appear to be related to the underlying condition or comorbidities such as nonalcoholic fatty liver disease or gallstone disease. Inebilizumab can cause hypersensitivity reactions including urticaria and rash, and liver injury might be a part of the immunoallergic reaction. Cases of reactivation of hepatitis B were not observed during prelicensure studies and should not occur with adequate prescreening and prophylaxis against reactivation.

### Outcome and Management

The product label for inebilizumab does not recommend monitoring of routine liver tests during therapy but does recommend screening for hepatitis B before starting therapy and obtaining advice from a hepatologist regarding prophylaxis. Nevertheless, de novo elevations of serum aminotransferase levels above 5 times the ULN or baseline values should lead to temporary discontinuation and evaluation for other possible causes of liver injury, restarting therapy only when values return to normal or near normal and with careful subsequent monitoring.

Drug Class: Neurological Disease Agents; Monoclonal Antibodies

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Inebilizumab – Uplizna®

DRUG CLASS

Neurological Disease Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Inebilizumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Inebilizumab | 1299440-37-1 (https://pubchem.ncbi.nlm.nih.gov/substance/381126899) | Monoclonal Antibody | Not Available

## SELECTED BIBLIOGRAPHY

References updated: 14 May 2024

Abbreviations: AntiAQP4, antibody to aquaporin-4; NMOSD, neuromyelitis optica spectrum disorder; ULN, upper limit of the normal range.

[Short Chapter information is based largely on FDA Product Labeling and the FDA Integrated Review accessible from the FDA website https://www.accessdata.fda.gov/scripts/cder/daf/index.cfm. All other references have not been fully reviewed and annotated.]

FDA. Integrated Review. 2020. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2020/761142Orig1s000MedR.pdf (FDA summary data on the safety and efficacy of inebilizumab, submitted in support of the application for approval as therapy of neuromyelitis optica spectrum disorder, mentions that ALT elevations arose in 21% of inebilizumab vs 23% of placebo recipients but were usually transient and mild, with one case of elevations above 5 times upper limit of normal [ULN] without jaundice that was shown to be due to acute cholangitis).
Chen D, Gallagher S, Monson NL, Herbst R, Wang Y. Inebilizumab, a B cell-depleting anti-CD19 antibody for the treatment of autoimmune neurological diseases: insights from preclinical studies. J Clin Med. 2016;5:107.27886126
Agius MA, Klodowska-Duda G, Maciejowski M, Potemkowski A, Li J, Patra K, Wesley J, et al. Safety and tolerability of inebilizumab (MEDI-551), an anti-CD19 monoclonal antibody, in patients with relapsing forms of multiple sclerosis: Results from a phase 1 randomised, placebo-controlled, escalating intravenous and subcutaneous dose study. Mult Scler. 2019;25:235-245.29143550
Frampton JE. Inebilizumab: first approval. Drugs. 2020;80:1259-1264.32729016
Cree BAC, Bennett JL, Kim HJ, Weinshenker BG, Pittock SJ, Wingerchuk DM, Fujihara K, et al; N-MOmentum study investigators. Inebilizumab for the treatment of neuromyelitis optica spectrum disorder (N-MOmentum): a double-blind, randomised placebo-controlled phase 2/3 trial. Lancet. 2019;394(10206):1352-1363.31495497
Rensel M, Zabeti A, Mealy MA, Cimbora D, She D, Drappa J, Katz E. Long-term efficacy and safety of inebilizumab in neuromyelitis optica spectrum disorder: Analysis of aquaporin-4-immunoglobulin G-seropositive participants taking inebilizumab for ⩾4 years in the N-MOmentum trial. Mult Scler. 2022;28:925-932.34595983
Bennett JL, Aktas O, Rees WA, Smith MA, Gunsior M, Yan L, She D; N-MOmentum study investigators. Association between B-cell depletion and attack risk in neuromyelitis optica spectrum disorder: An exploratory analysis from N-MOmentum, a double-blind, randomised, placebo-controlled, multicentre phase 2/3 trial. EBioMedicine. 2022;86:104321.36370634
Cai L, Liu X, Zhou H, Li J, Zhou D, Hong Z. Case report: Identification of hepatitis B virus in the cerebrospinal fluid of neuromyelitis optica spectrum disorders and successful treatment with ofatumumab and inebilizumab. Front Immunol. 2024 Feb 15;15:1351782.38426084

## OTHER REFERENCE LINKS

1. Recent References on Inebilizumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Inebilizumab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Inebilizumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Inebilizumab)